# Thalidomide

## OVERVIEW

### Introduction

Thalidomide and its analogue lenalidomide are immunomodulatory and antineoplastic agents that are used in the therapy of multiple myeloma. Both agents are associated with a low rate of serum aminotransferase elevations during therapy and both have been implicated in causing rare instances of clinically apparent liver injury which can be severe.

### Background

Thalidomide (tha lid' oh mide) is a glutamic acid derivative that was introduced in Europe as a sedative in the late 1950s and subsequently withdrawn in 1961 when it was shown to be teratogenic, causing severe infant limb defects (phocomelia) when given to pregnant women. Several decades later, thalidomide was found to have potent activity in erythema nodosum leprosum, and subsequent studies found it beneficial in several autoimmune conditions and cancers. Thalidomide has immunomodulatory, antiinflammatory, antiangiogenic and anticancer properties that underlie its effects in inflammatory and malignant diseases. Thalidomide was approved for therapy of erythema nodosum leprosum (ENL) in the United States in 1998 and was subsequently approved for use in multiple myeloma (in combination with dexamethasone) in 2006. Lenalidomide (len" a lid' oh mide) is a thalidomide derivative that was found to be more potent as an antineoplastic agent, and was approved for use in selected myelodysplastic syndromes in 2005 and for multiple myeloma (combined with dexamethasone) in 2006. Thalidomide has also been used on an experimental basis for graft vs host disease, Kaposi sarcoma, AIDS associated wasting syndrome and several forms of autoimmune disease. Thalidomide is available in capsules of 50, 100, 150 and 200 mg under the brand name Thalomid, and lenalidomide in capsules of 2.5, 5, 10, 15, 20 and 25 mg under the brand name Revlimid. The recommended doses vary by indication, and their use is restricted because of their proven teratogenicity. Side effects of thalidomide and lenalidomide are common and include sedation, dizziness, orthostatic hypotension, neutropenia, peripheral neuropathy, and venous thromboembolism (for which reason they are often given with anticoagulation).

### Hepatotoxicity

Serum enzyme elevations occur in 8% to 15% of patients taking thalidomide or lenalidomide and are more frequent with higher doses. The enzyme abnormalities are usually mild and self-limited, and only rarely require drug discontinuation. In addition, both thalidomide and lenalidomide have been implicated in rare instances of clinically apparent, acute liver injury which can be severe and has led to deaths from acute liver failure. The onset of injury is typically within 1 to 8 weeks of starting therapy. The pattern of serum enzyme elevation at the time of presentation can be either hepatocellular or cholestatic; however, the injury tends to be cholestatic and can be prolonged. Immunoallergic and autoimmune features are not common. Several instances of acute liver injury associated with thalidomide and lenalidomide therapy have occurred in patients with other apparent causes of liver disease or with preexisting chronic hepatitis B or C. If performed during the acute injury, liver biopsy shows hepatocellular necrosis and inflammatory cell infiltration, consistent with acute drug induced injury. In some instances there is bile duct injury and loss resulting in progressive cholestatic liver injury suggestive of vanishing bile duct syndrome.

Likelihood score: B (well known but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of thalidomide and lenalidomide hepatotoxicity is not clear, but it may be related to their activity in reducing TNF-α production, a potent inflammatory cytokine that activates T cells and promotes inflammation, but is also necessary for normal liver regeneration. Several of the reported cases of hepatotoxicity have occurred in patients with underlying chronic liver disease (hepatitis B, C or nonalcoholic fatty liver), and another possibility is that thalidomide or lenalidomide may worsen preexisting hepatic conditions.

### Outcome and Management

The severity of thalidomide and lenalidomide induced liver injury ranges from transient, asymptomatic elevations in serum enzymes to acute liver injury with jaundice to severe acute liver failure and death. The liver injury usually starts to resolve within a week of stopping the medication, but prolonged jaundice with bile duct injury and possible vanishing bile duct syndrome have also been reported. Rechallenge should be reserved for cases of mild liver injury in which the agent is considered very necessary and done with caution and careful monitoring. Nevertheless, instances of reinitiation of therapy without subsequent recurrence of liver injury have been reported.

Drug Class: Antineoplastic Agents, Miscellaneous

Other Related Drugs: Pomalidomide

## CASE REPORT

### Case 1. Acute hepatitis due to thalidomide.

[Modified from: Hanje AJ, Shamp JL, Thomas FB, Meis GM. Thalidomide-induced severe hepatotoxicity. Pharmacotherapy 2006; 26: 1018-22. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16803426)].

A 76 year old woman with multiple myeloma developed jaundice 5 weeks after starting thalidomide combined with warfarin and intermittent dexamethasone. She had no previous history of liver disease or risk factors for viral hepatitis. She did not drink alcohol. Her only other medications were metoprolol and furosemide for hypertension and insulin for diabetes. Routine liver tests had been normal in the past. Routine monitoring of serum enzymes demonstrated rises in ALT and AST after 4 weeks of treatment. Thalidomide was continued, and one week later she developed nausea, fatigue, abdominal discomfort and jaundice. On physical examination, she was jaundiced but had no fever, rash or signs of chronic liver disease. Laboratory tests showed bilirubin 5.6 mg/dL, ALT 2206 U/L, and international normalized ratio (INR) of greater than 15. She was admitted to the hospital for management and both thalidomide and the warfarin were stopped. Tests for hepatitis A, B and C were negative as were autoantibodies. Imaging of the liver showed evidence of diffuse fatty liver, but no masses or biliary obstruction. She was treated with fresh frozen plasma to correct the INR and underwent transjugular liver biopsy which was interpreted as compatible with acute drug induced liver injury superimposed upon an underlying nonalcoholic steatohepatitis. After thalidomide was stopped, she began to improve rapidly (Table). She was discharged after a week in the hospital and, when seen three months later, her liver tests were normal.

#### Key Points

Medication: | Thalidomide
Pattern: | Hepatocellular (R value could not be determined)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 4 to 5 weeks
Recovery: | Complete within 30 days
Other medications: | Furosemide, metoprolol, insulin, warfarin, dexamethasone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | | Normal
4 weeks | | 218 | 179
5 weeks | 0 | 2205 | 2376 | 5.6 | INR >15, admission
| 1 day | 2250 | 2425 | | Thalidomide stopped
| 4 days | 1500 | 1050
6 weeks | 12 days | 165 | 86 | 5.5 | INR 1.1: Discharged
4 months | 3 months | Normal | Normal | Normal | Outpatient follow up
Normal Values | | <34 | <35 | <1.2

* Some values estimated from Figure 1.

#### Comment

This woman developed jaundice within 5 weeks of starting an experimental regimen of cancer chemotherapy including thalidomide, warfarin and dexamethasone. Typical of thalidomide hepatotoxicity was the latency to onset (1 to 3 months), the hepatocellular pattern of injury (although no alkaline phosphatase values were provided in this case), the presence of an underlying liver disease, and the rapid improvement with stopping the medication.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Thalidomide – Thalidomid®

Lenalidomide – Revlimid®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Thalidomide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thalidomide | 50-35-1 | C13-H10-N2-O4 | Thalidomide Chemical Structure
Pomalidomide | 19171-19-8 | C13-H11-N3-O4
Lenalidomide | 191732-72-6 | C13-H13-N3-O3 | Lenalidomide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; thalidomide is not discussed).
Davern TJ. Hepatotoxicity of immunomodulating agents and the transplant situation. Thalidomide. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, p. 675. (Mentions that thalidomide rarely causes liver injury, but case reports of hepatocellular injury with variable degrees of jaundice have been described, largely in patients with preexisting chronic liver disease).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Thalidomide. Target therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1340-2. (Textbook of pharmacology and therapeutics).
Hastings RC, Trautman JR, Enna CD, Jacobson RR. Thalidomide in the treatment of erythema nodosum leprosum. With a note on selected laboratory abnormalities in erythema nodosum leprosum. Clin Pharmacol Ther 1970; 11: 481-7. (Results of treating 22 patients with leprosy with thalidomide showed excellent results, often allowing for discontinuation of corticosteroids without significant toxicity). 4913866
Tseng S, Pak G, Washenik K, Pomeranz MK, Shupack JL. Rediscovering thalidomide: a review of its mechanism of action, side effects, and potential uses. J Am Acad Dermatol 1996; 35: 969-79. (Review of history, mechanism of action, side effects and uses of thalidomide; thalidomide has many side effects, but hepatic adverse events were not mentioned). 8959957
Singhal S, Mehta J, Desikan R, Ayers D, Roberson P, Eddlemon P, Munshi N, et al. Antitumor activity of thalidomide in refractory multiple myeloma. N Engl J Med 1999; 341: 1565-71. (Trial of oral thalidomide in 84 patients with advanced myeloma found some response in 78% and remissions in 10%; adverse events were common, but no mention of ALT elevations or liver injury). 10564685
Clark T, Edom N, Larson J, Lindsey LJ. Thalidomide: a review of the first 18 months of spontaneous postmarketing adverse event surveillance, including off-label prescribing. Drug Saf 2001; 24: 87-117. (During first 18 months of postmarketing use of thalidomide in 10,456 patients, 1210 adverse event reports were received, including 4 cases of hepatic failure arising after 1-4 weeks of treatment, although 3 were considered unrelated to therapy). 11235821
Fowler R, Imrie K. Thalidomide-associated hepatitis: a case report. Am J Hematol 2001; 66: 300-2. (Patient with chronic hepatitis C and advanced plasma cell leukemia developed jaundice and nausea 1 week after starting thalidomide [bilirubin 0.4 initially rising to 9.3 mg/dL, ALT 91 to 829 U/L, Alk P 100 to 120 U/L], resolving rapidly upon stopping; high HCV RNA levels noted). 11279644
Grover JK, Uppal G, Raina V. The adverse effects of thalidomide in relapsed and refractory patients of multiple myeloma. Ann Oncol 2002; 13: 1636-40. (Report of adverse effects of thalidomide in 23 patients with myeloma: constipation 100%, sedation 87%, edema 70%, also common were dry skin and mouth, headache, nausea and rash; minor ALT elevations occurred and 1 patient developed acute hepatitis, but it was attributed to hepatitis C). 12377654
Ghobrial IM, Rajkumar SV. Management of thalidomide toxicity. J Support Oncol 2003; 1: 194-205. (Discussion of management of toxicities of thalidomide focusing upon sedation, constipation, neuropathy, rash, deep vein thrombosis, neutropenia, bradycardia and seizures; "elevated liver enzymes may occur in some patients"). 15334875
Seldin DC, Choufani EB, Dember LM, Wiesman JF, Berk JL, Falk RH, O'Hara C, et al. Tolerability and efficacy of thalidomide for the treatment of patients with light chain-associated (AL) amyloidosis. Clin Lymphoma 2003; 3: 241-6. (Among 16 patients with amyloidosis given thalidomide to maximum tolerated dose, side effects included fatigue, sedation, constipation, headaches, fluid retention, and changes in thyroid tests and creatinine; no mention of liver abnormalities). 12672274
Trojan A, Chasse E, Gay B, Pichert G, Taverna C. Severe hepatic toxicity due to thalidomide in relapsed multiple myeloma. Ann Oncol 2003; 14: 501-2. (62 year old woman with multiple myeloma developed acute liver failure after 7 months of thalidomide therapy [bilirubin not given, ALT ~2000 U/L, LDH ~6000 U/L], enzymes falling to normal in 1 week; overall, suggestive of ischemic hepatitis rather than hepatotoxicity). 12598363
Teo SK. Properties of thalidomide and its analogues: implications for anticancer therapy. AAPS Journal 2005; 7: E14-D19. (Review of the properties and experimental uses of thalidomide as an inhibitor of TNF-α and other cytokines in multiple myeloma and several solid tumors). 16146335
List A, Kurtin S, Roe DJ, Buresh A, Mahadevan D, Fuchs D, Rimsza L, et al. Efficacy of lenalidomide in myelodysplastic syndromes. N Engl J Med 2005; 352: 549-57. (Open label study of lenalidomide in 43 patients with myelodysplasia and anemia due to myelodysplastic syndrome reported neutropenia in 65% and thrombocytopenia in 74% of patients, and need for dose modification in 25%, but no mention of liver abnormalities). 15703420
Caseiro MM. Treatment of chronic hepatitis C in non-responsive patients with pegylated interferon associated with ribavirin and thalidomide: report of six cases of total remission. Rev Inst Med Trop Sao Paulo 2006; 48: 109-12. (Report of improvement in virological and biochemical responses to peginterferon and ribavirin therapy of chronic hepatitis C by addition of thalidomide [100 mg daily]; no mention of side effects). 16699635
Hanje AJ, Shamp JL, Thomas FB, Meis GM. Thalidomide-induced severe hepatotoxicity. Pharmacotherapy 2006; 26: 1018-22. (Elderly woman with myeloma developed jaundice and marked ALT elevations after 6 weeks of thalidomide therapy [ALT 2205 U/L; bilirubin 5.6 mg/dL], resolving within 3 months of stopping: Case 1). 16803426
Hamadani M, Benson DM Jr, Copelan EA. Thalidomide-induced fulminant hepatic failure. Mayo Clin Proc 2007; 82: 638. (64 year old woman with multiple myeloma and HBsAg in serum developed acute liver failure 12 days after starting thalidomide [bilirubin 16.7 mg/dL, ALT 410 U/L, Alk P 101 U/L, no change in HBV DNA], some improvement on stopping drug, but had worsening coagulopathy and renal failure and died 14 days later). 17493431
Melchert M, List A. The thalidomide saga. IJBCB 2007; 39: 1489-99. (Review of history of thalidomide and current understanding of its actions as an anticytokine; no mention of side effects). 17369076
Hussain S, Browne R, Chen J, Parekh S. Lenalidomide-induced severe hepatotoxicity. Blood 2007; 110: 3814. (57 year old man with multiple myeloma developed jaundice 1 week after starting lenalidomide, a derivative of thalidomide [bilirubin 7.2 mg/dL, ALT 90 U/L, Alk P 210 U/L], resolving within 3 weeks). 17984315
Weber DM, Chen C, Niesvizky R, Wang M, Belch A, Stadtmauer EA, Siegel D, et al.; Multiple Myeloma (009) Study Investigators. Lenalidomide plus dexamethasone for relapsed multiple myeloma in North America. N Engl J Med 2007; 357: 2133-42. (Controlled trial of lenalidomide in 353 patients with relapsed multiple myeloma showed improvement in response rates and survival time; side effects were common, but no mention of liver abnormalities). 18032763
Dimopoulos M, Spencer A, Attal M, Prince HM, Harousseau JL, Dmoszynska A, San Miguel J, et al.; Multiple Myeloma (010) Study Investigators. Lenalidomide plus dexamethasone for relapsed or refractory multiple myeloma. N Engl J Med 2007; 357: 2123-32. (Controlled trial of lenalidomide in 351 patients with refractory multiple myeloma showed improvement in response rates and survival time; side effects of neutropenia, muscle cramps, constipation, nausea and dizziness were common, but liver abnormalities were not mentioned). 18032762
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to thalidomide or lenalidomide). 18955056
Dabak V, Kuriakose P. Thalidomide-induced severe hepatotoxicity. Cancer Chemother Pharmacol. 2009; 63: 583-5. (2 women with multiple myeloma; 79 year old developed jaundice 7 weeks after starting thalidomide [bilirubin 27.9 mg/dL, ALT 392 U/L, Alk P 1172 U/L], with persistent jaundice, bile duct loss on liver biopsy and death 4 months later; 57 year old developed raised enzymes one month after starting thalidomide [bilirubin not given, ALT 398 U/L, Alk P 175 U/L], resolving within 2 weeks of stopping). 19083237
Levesque E, Bradette M. Hepatotoxicity as a rare but serious side effect of thalidomide. Ann Hematol 2009; 88: 183-4. (36 year old woman with multiple myeloma developed liver test abnormalities 5 weeks after starting thalidomide [bilirubin normal, peak ALT ~1300 U/L], resolving within 20 days of stopping). 18665361
Jain P. Lenalidomide-induced acute liver failure. Blood Transfus 2009; 7: 335-6; author reply 337. (93 year old man with myelodysplastic syndrome and HBsAg in serum developed jaundice 10 days after starting lenalidomide [bilirubin 9.2 mg/dL, ALT 2670 U/L, Alk P 342 U/L, IgM anti-HBc positive, but HBV DNA negative], resolving over following 4 weeks and patient later tolerated restarting lenalidomide in combination with adefovir). 20011646
Castaneda CP, Brandenburg NA, Bwire R, Burton GH, Zeldis JB. Erythema multiforme/Stevens-Johnson syndrome/toxic epidermal necrolysis in lenalidomide-treated patients. J Clin Oncol 2009; 27: 156-7. (After approximately 57,000 patients had received lenalidomide, the sponsor received 12 reports of Stevens-Johnson Syndrome, 3 of erythema multiforme and 1 of toxic epidermal necrolysis, arising 3-112 days after starting; often sparse data were available and there was no mention of liver injury or jaundice). 19047275
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to thalidomide). 20949552
Zanella MC, Rubbia-Brandt L, Giostra E, Chalandon Y, Hadengue A, Spahr L. A Case of drug-induced hepatitis due to lenalidomide. Case Rep Gastroenterol 2011; 5: 217-22. (50 year old man developed severe skin rash 3 months after starting lenalidomide that resolved upon stopping, but developed serum enzyme elevations one week after restarting lenalidomide 2 years later [bilirubin normal, ALT 509 U/L, Alk P 198 U/L], resolving upon stopping). 21552449
Vilas-Boas F, Gonçalves R, Sobrinho Simões M, Lopes J, Macedo G. Thalidomide-induced acute cholestatic hepatitis: Case report and review of the literature. Gastroenterol Hepatol 2012; 35: 560-6. (77 year old man with multiple myeloma developed jaundice 4 weeks after starting chemotherapy with melphalan, prednisone and thalidomide [bilirubin 11.4 mg/dL, ALT 333 U/L, Alk P 4 times ULN], worsening for a week after stopping thalidomide and then improving; patient later tolerated melphalan, but died of pneumonia shortly thereafter). 22789729
Shao YY, Lin ZZ, Hsu C, Lee KD, Hsiao CH, Lu YS, Huang CC, et al. Efficacy, safety, and potential biomarkers of thalidomide plus metronomic chemotherapy for advanced hepatocellular carcinoma. Oncology 2012; 82: 59-66. (Pilot study of thalidomide combined with tegafur for advanced hepatocellular carcinoma in 43 patients; ALT/AST levels rose above 5 times ULN in 2 patients [5%], but no details given). 22310088
Rance E, Tanner JE, Alfieri C. Inhibition of IκB kinase by thalidomide increases hepatitis C virus RNA replication. J Viral Hepat 2012; 19: e73-80. (In cell culture, thalidomide lowered IL8 and NF kappa B and markedly increased HCV replication [17 fold], an effect reversed by increasing NF kappa B signaling). 22239529
Garrido Serrano A, León R, Sayago M, Márquez JL. Thalidomide treatment in cirrhotic patients with severe anemia secondary to vascular malformations. Dig Dis Sci 2012; 57: 1112-3. (Pilot study of thalidomide in 19 patients with cirrhosis and recurrent gastrointestinal bleeding; thalidomide therapy appeared to decrease bleeding episodes, but 8 subjects [42%] developed hepatic encephalopathy, 2 discontinued drug because of side effects, and 2 died). 22089255
Nojkov B, Signori C, Konda A, Fontana RJ. Lenalidomide-associated hepatotoxicity--a case report and literature review. Anticancer Res 2012; 32: 4117-9. (67 year old man with multiple myeloma developed fatigue within 1 week of starting a 2nd 3 week course of lenalidomide [bilirubin 4.4 mg/dL, ALT 139 U/L, Alk P 190 U/L], with rapid resolution upon stopping [within 8 days]). 22993370
Veluswamy RR, Ward SC, Yum K, Abramovitz RB, Isola LM, Jagannath S, Parekh S. Adverse drug reaction: pomalidomide-induced liver injury. Lancet 2014; 383 (9935): 2125-6. (50 year old man with multiple myeloma on lenalidomide and dexamethasone after HCT developed ALT elevations [433 U/L], which resolved on stopping but recurred and worsened when later treated after a second HCT with pomalidomide and dexamethasone [bilirubin 13 mg/dL, ALT 3981 U/L, Alk P 259 U/L], resolving after stopping both drugs, but ultimately requiring corticosteroid therapy). 24953475
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to thalidomide or its derivatives). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 1 case was attributed to thalidomide). 25754159
Mahale P, Thomas SK, Kyvernitakis A, Torres HA. Management of multiple myeloma complicated by hHepatitis C virus reactivation: the role of new antiviral therapy. Open Forum Infect Dis 2015; 3: ofv211. (74 year old woman with multiple myeloma and chronic hepatitis C had worsening of serum ALT and increase in HCV RNA levels when treated with thalidomide and dexamethasone, which prevented continued therapy until hepatitis C was successfully treated with sofosbuvir and ribavirin). 26885541
Safran H, Charpentier KP, Kaubisch A, Mantripragada K, Dubel G, Perez K, Faricy-Anderson K, et al. Lenalidomide for second-line treatment of advanced hepatocellular cancer: a Brown University oncology group phase II study. Am J Clin Oncol 2015; 38: 1-4. (Among 40 patients with hepatocellular carcinoma with an inadequate response to sorafenib treated with lenalidomide [25 mg daily for 21 days in 28 day cycles] 6 [15%] had a partial response and toxicities were largely hematologic and rash; 5 patients had ALT elevations above 3 times ULN). 23648434
Kootte RS, Faber LM. Hepatitis E during lenalidomide treatment for multiple myeloma in complete remission. Neth J Med 2017; 75: 117-21. (69 year old woman with multiple myeloma on lenalidomide after HCT was found to have elevations in liver tests [bilirubin 0.5 mg/dL, ALT 328 U/L, Alk P 241 U/L] accompanied by IgM anti-HEV and HEV RNA [suggesting chronic infection sustained by immunosuppression], viremia and ALT elevations resolving with stopping lenalidomide and not returning when it was restarted). 28469048
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 1 case attributed to lenalidomide and 1 to thalidomide both marked by severe, and relentlessly progressive cholestatic liver injury resulting in death from liver failure within 3 months of onset). 27981596

## OTHER REFERENCE LINKS

1. Recent References on Thalidomide, Lenalidomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lenalidomide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Thalidomide, Lenalidomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lenalidomide)